# Lovastatin

## OVERVIEW

### Introduction

Lovastatin is a commonly used cholesterol lowering agent (statin) that is associated with mild, asymptomatic and self-limited serum aminotransferase elevations during therapy and rarely with clinically apparent acute liver injury.

### Background

Lovastatin (loe" va stat' in) is an orally available inhibitor of hepatic 3-hydroxy-3-methylglutaryl-coenzyme A (HMG-CoA) reductase, the major rate-limiting enzyme in cholesterol synthesis. Like other members of its class (the “statins”), lovastatin lowers total serum cholesterol and low density lipoprotein (LDL) concentrations, thereby reducing the risk of atherosclerosis and its complications – myocardial infarction and stroke. Lovastatin is indicated for treatment of hypercholesterolemia in persons at high risk for coronary, cerebrovascular and peripheral artery disease. It is also indicated for prevention of cardiovascular disease and to decrease the risk of progression in patients with known coronary artery disease. Lovastatin is available in tablets of 10, 20, and 40 mg in generic forms and under the brand name Mevacor. Extended release forms (Altoprev) and fixed combinations with niacin (Advicor) are also available. The recommended adult dose is 10 to 80 mg daily in single or two divided doses based upon tolerability and lipid levels. Lovastatin was approved for use in the United States in 1987, the first of this class of drugs to be commercially available. Lovastatin is a widely prescribed drug with more than 7 million prescriptions filled yearly. Common side effects include muscle cramps, headache, joint aches, abdominal pain, nausea, and weakness, symptoms that occur with all of the currently available statins. Rare but potentially severe adverse events include liver injury, myopathy, rhabdomyolysis, and immune-mediated necrotizing myopathy.

### Hepatotoxicity

Lovastatin therapy is associated with mild, asymptomatic and usually transient serum aminotransferase elevations. In summary analyses of large scale studies with prospective monitoring, ALT elevations above normal occurred in 3% to 5% of patients, but were above 3 times the upper limit of normal (ULN) in only 0.4% compared to 0.1% of placebo recipients. These elevations were more common with higher doses of lovastatin, being greater than 3 times ULN in 0.1% of patients receiving 20 mg daily, 0.9% with 40 mg and 1.5% with 80 mg daily. Most of these elevations were self-limited and did not require dose modification, although discontinuation is recommended for any elevation above 10 times and for persistent elevations above 5 times the ULN. Lovastatin is also associated with frank, clinically apparent hepatic injury, but cases are rare. The onset of clinical injury ranges from a few weeks to several years. The pattern of injury is typically cholestatic, but can be hepatocellular. Rash, fever and eosinophilia are uncommon as are autoimmune features. The injury usually resolves rapidly upon stopping lovastatin, but instances of fatal acute liver failure and of prolonged cholestasis have been reported (Case 1).

The traditional Chinese medication known as red yeast rice which is used to treat hyperlipidemia has been shown to contain monacolin K, a natural component that is chemically identical to lovastatin, perhaps explaining its efficacy in reducing cholesterol levels. Red yeast rice has also been implicated in cases of acute liver injury and myopathies that are similar to those linked to lovastatin. In some instances cross-sensitivity to hepatic injury has been shown between red yeast rice products and lovastatin.

Likelihood score: B (likely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of hepatic injury from lovastatin is unknown. Lovastatin is largely metabolized in the liver (via CYP 3A4) and metabolites are excreted in bile. Lovastatin is susceptible to drug-drug interactions and strong inhibitors of CYP 3A4 can result in higher plasma lovastatin levels which increases the risk of muscle and liver injury. The mild, self-limited ALT elevations are likely due to a toxic intermediate of drug metabolism and the reversal of these elevations due to adaptation. The idiosyncratic, clinically apparent liver injury associated with lovastatin is probably immunologically mediated.

### Outcome and Management

The product label for lovastatin recommends screening for liver test abnormalities before starting therapy and repeating tests as clinically indicated. The ALT elevations that occur with lovastatin therapy usually resolve spontaneously within a few weeks even without discontinuation. The product label for lovastatin mentions rare cases of acute liver failure due to lovastatin, some of which were fatal. There have not been fatal instances of acute liver injury attributable to lovastatin in the published literature. In the average case, recovery is expected within 1 to 2 months of stopping lovastatin, but instances of prolonged cholestasis and some degree of vanishing bile duct syndrome have been reported. In view of the wide scale use of lovastatin, clinically apparent and severe liver injury is extraordinarily rare. Recurrence of injury with rechallenge has been reported and should be avoided. Switching therapy to another statin after lovastatin induced injury is apparently safe, but few instances have been reported, and it should be done with careful monitoring for recurrence.

Drug Class: Antilipemic Agents

Other Drugs in the Subclass, Statins: Atorvastatin, Ezetimibe [used in combination], Fluvastatin, Pitavastatin, Pravastatin, Rosuvastatin, Simvastatin

## CASE REPORT

### Case 1. Cholestatic hepatitis due to lovastatin therapy.(1)

A 40 year old man developed fatigue, dark urine, jaundice and itching approximately 11 weeks after starting lovastatin (20 mg daily). He had no previous history of liver disease and drank little alcohol. He had a past history of kidney stones, hyperlipidemia and hypertension, and his other medications included allopurinol (100 mg daily) and the combination of hydrochlorothiazide and amiloride. Liver tests had been normal in the past. When he was finally seen and evaluated, 17 weeks after starting therapy, laboratory tests showed a mixed pattern of serum enzyme elevations. Tests for hepatitis A and B and for autoantibodies were negative. An ultrasound of the abdomen showed evidence suggestive of bile duct dilatation, but ERCP was normal. Lovastatin was stopped and he improved symptomatically. Liver tests had improved but were not completely normal six months later.

#### Key Points

Medication: | Lovastatin (20 mg daily)
Pattern: | Mixed (R=4.7)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 11 weeks to symptoms
Recovery: | 6 months
Other medications: | Allopurinol, hydrochlorothiazide, amiloride

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | 25 | 77 | | Lovastatin started
7 weeks | | 38 | 64
17 weeks | 0 | 381 | 277 | | Lovastatin stopped
19 weeks | 10 days | 337 | 381
21 weeks | 4 weeks | 205 | | 6.5
6 months | 2 months | 229 | 133 | 1.9
10 months | 6 months | 65 | 112
Normal Values | | <35 | <120 | <1.2

* Some values estimated from Figure 1.

#### Comment

The patient had symptoms of a cholestatic hepatitis with prominence of jaundice and itching. There was a delay in stopping lovastatin and the cholestatic hepatitis was prolonged. At the time of this report, lovastatin had been available for only approximately a year, and 3 cases of jaundice possibly related to lovastatin had already been reported to the Food and Drug Administration (MedWatch).

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lovastatin – Generic, Altoprev®, Mevacor®

DRUG CLASS

Antilipemic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=lovastatin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Lovastatin | 75330-75-5 | C24-H36-O5

CITED REFERENCE

1 McQueen MJ. (1990). Cholestatic jaundice associated with lovastatin (Mevacor) therapy. Can Med Assoc J.

## ANNOTATED BIBLIOGRAPHY

References updated: 01 December 2021

Abbreviations used: ANA, antinuclear antibody; HDL, high density lipoprotein; LDL, low density lipoprotein; OD, odds ratio.

Zimmerman HJ. Drugs used in the treatment of hypercholesterolemia and hyperlipidemia. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 660-2. (Expert review of hepatotoxicity published in 1999; the statins have dose related hepatic effects in guinea pigs and rabbits, and transient elevations in aminotransferases occur in 1-5% of humans treated; several cases of clinically apparent liver injury from lovastatin and simvastatin have been published).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic medications. Lipid lowering agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 519-40. (Review of hepatotoxicity of lipid lowering agents; asymptomatic elevations in aminotransferases are common in patients receiving statins, but clinically significant hepatotoxicity is rare).
Gurgle H, Blumenthal DK. Drug therapy for dyslipidemias. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 605-618. (Textbook of pharmacology and therapeutics; “Serious hepatotoxicity is rare and unpredictable, with a rate of about 1 case per million person-years of use.” Multiple academic societies and the FDA recommend testing all patients for routine liver tests before starting statins but monitoring or retesting only if symptoms arise).
Stein EA, Lamkin GE, Bewley DZ. (1988). Lovastatin alone and in combination for treatment of primary hypercholesterolemia. Prog Clin Biol Res. (Controlled trial comparing lovastatin to niacin in 80 patients, one lovastatin treated patient had transient ALT elevation >3 times ULN).
The Lovastatin Study Group III. (1988). A multicenter comparison of lovastatin and cholestyramine therapy for severe primary hypercholesterolemia. JAMA. (Controlled trial of lovastatin [20 or 40 mg/day] vs cholestyramine [16 g/day] for 12 weeks in 264 patients with hypercholesterolemia; ALT levels increased more frequently in cholestyramine treated patients, and ALT levels >2 times ULN occurred in 9% of cholestyramine vs 1% of lovastatin treated patients).
Tobert JA. (1988). Efficacy and long-term adverse effect pattern of lovastatin. Am J Cardiol. (Long term safety study of 744 patients receiving lovastatin, 9 [1.2%] developed raised serum enzymes).
Mantell G, Burke MT, Staggers J. (1990). Extended clinical safety profile of lovastatin. Am J Cardiol. (Review of safety data on lovastatin from extensions of prelicensure clinical trials and the first year of postmarketing adverse event reporting; in clinical trials in 744 patients, rates of ALT elevations >3 times ULN were 0.1% on placebo vs 0.1% on 20 mg, 0.7% on 40 mg, and 1.5% on 80 mg of lovastatin daily; 49 cases of liver toxicity reported to MedWatch, but most could not be verified and most resolved spontaneously, but two positive rechallenges and two deaths from liver disease, although they were considered not drug related).
Bilheimer DW. (1990). Long-term clinical tolerance of lovastatin and simvastatin. Cardiology. (Review; serum enzyme elevations occur in 1.3% of lovastatin treated patients, reversible upon discontinuation of drug).
McQueen MJ. (1990). Cholestatic jaundice associated with lovastatin (Mevacor) therapy. Can Med Assoc J. (40 year old man developed jaundice 11 weeks after starting lovastatin [peak bilirubin 6.5 mg/dL, ALT 381 U/L, Alk P 381 U/L], resolving, but not completely, within 6 months of stopping: Case 1).
Geddes JA. (1990). Cholestatic jaundice associated with lovastatin (Mevacor) therapy. Can Med Assoc J. (72 year old woman developed jaundice 13 months after starting lovastatin [bilirubin 1.8 mg/dL, AST 177 U/L, Alk P 351 U/L], resolving within 4 weeks of stopping, but also exposed to cloxacillin 2 weeks before onset of jaundice).
Spreckelsen U, Kirchoff R, Haake H. (1991). [Cholestatic jaundice during lovastatin medication] (German). Dtsch Med Wochenschr. (48 year old man developed jaundice 8 weeks after starting lovastatin [bilirubin 6.2 mg/dL, ALT 341 U/L, Alk P 389 U/L], resolving within 2 weeks of stopping).
Bradford RH, Shear RL, Chremos AN, Dujovne C, Downton M, Franklin FA, Gould AL, et al. (1991). Expanded clinical evaluation of lovastatin (EXCEL) study results. I. Efficacy in modifying lipoproteins and adverse events profile of 8245 patients with moderate hypercholesterolemia. Arch Intern Med. (Large, randomized controlled trial of 3 doses of lovastatin vs placebo in 8245 patients; serum ALT or AST elevations >3 times ULN occurred in 0.1% on placebo, 0.1% on 20 mg, 0.9% on 40 mg, and 1.5% on 80 mg of lovastatin daily).
Raveh D, Arnon R, Israeli A, Eisenberg S. (1992). Lovastatin-induced hepatitis. Isr J Med Sci. (50 year old woman developed enzyme elevations and marked pruritus 7 months after starting lovastatin [bilirubin 0.7 mg/dL, ALT 296 U/L, Alk P 626 U/L], with prompt disappearance of symptoms, but slow improvement in abnormal liver tests upon stopping lovastatin).
The Lovastatin Pravastatin Study Group. (1993). A multicenter comparative trial of lovastatin and pravastatin in the treatment of hypercholesterolemia. Am J Cardiol. (Controlled trial of lovastatin [20 to 80 mg] vs pravastatin [10 to 40 mg] daily for 18 weeks in 672 hypercholesterolemic patients; ALT elevations >3 times ULN occurred in 1 lovastatin and 2 pravastatin treated patients; no clinically apparent liver injury mentioned).
Grimbert S, Pessayre D, Degott C, Benhamou JP. (1994). Acute hepatitis induced by HMG-CoA reductase inhibitor, lovastatin. Dig Dis Sci. (64 year old man developed jaundice 12 weeks after starting lovastatin [bilirubin 11.7 mg/dL, ALT 8 times and Alk P 1.5 times ULN], resolving within 2 months of stopping).
LaRosa JC, Applegate W, Crouse JR, Hunninghake DB, Grimm R, Knopp R, Eckfeldt JH, et al. (1994). Cholesterol lowering in the elderly: results of the cholesterol reduction in seniors program (CRISP) pilot study. Arch Intern Med. (Controlled trial of lovastatin vs placebo in 431 patients; average ALT levels were identical and constant in all 3 groups during treatment).
Furberg CD, Adams HP, Applegate WB, Byington RP, Espeland MA, Hartwell T, Hunninghake DB, et al. (1994). Effect of lovastatin on early carotid atherosclerosis and cardiovascular events. Asymptomatic carotid artery progression study (ACAPS) research group. Circulation. (No comment on liver injury in this double blind randomized controlled clinical trial).
Bradford RH, Shear RL, Chremos AN, Cujovne CA, Franklin FA, Grillo RB, Higgins J, et al. (1994). Expanded clinical evaluation of lovastatin (EXCEL) study results. Two year efficacy and safety follow up. Am J Cardiol. (Controlled trial of lovastatin [20 mg daily] vs placebo in 8245 patients with hypercholesterolemia; confirmed ALT elevations >3 times ULN occurred in only 1 patient on lovastatin during year 2, and no episodes of clinically apparent liver disease; rates of ALT elevations >3 times ULN were 0.1% for placebo and 20 mg, 0.9% for 40 mg, and 1.9% for 80 mg daily).
Huchzermeyer H, Munzenmaier R. (1995). Dtsch Med Wochenschr. (58 year old man and 54 year old woman developed cholestatic hepatitis 3 years and 2 months after starting lovastatin [peak bilirubin 15.0 and 9.2 mg/dL, ALT 276 and 384 U/L, Alk P 1227 and 595 U/L], both cases resolving slowly after stopping).
Gavilán Carrasco JC, Bermúdez Recio F, Salgado Ordóñez F, González Santos P. (1996). Med Clin (Barc). (51 year old with epilepsy on long term phenytoin, phenobarbital and valproate therapy developed jaundice 6 weeks after starting lovastatin [bilirubin 15 mg/dL, ALT 4000 U/L, Alk P 662 U/L], resolving within 2 months of stopping; restarted on phenobarbital and carbamazepine without recurrence).
Bruguera M, Joya P, Rodés J. (1998). Gastroenterol Hepatol. (Two women, ages 57 and 59 years, developed symptomatic but anicteric hepatitis 9 months and 3 years after starting lovastatin [bilirubin 0.8 and 1.3 mg/dL, ALT 244 and 273 U/L, Alk P 845 and 306 U/L], resolving rapidly on stopping).
Downs JR, Clearfield M, Weis S, Whitney E, Shapiro DR, Beere PA, Langendorfer A, et al. (1998). Primary prevention of acute coronary events with lovastatin in men and women with average cholesterol levels. Results of AFCAPS/TexCAPS. JAMA. (Controlled trial of lovastatin in 9905 patients; AST or ALT elevations >3 times ULN occurred in 0.7% on 20 mg and 0.4% on 40 mg of lovastatin, and 0.3% on placebo).
de Denus S, Spinler SA, Miller K, Peterson AM. (2004). Statins and liver toxicity: a meta-analysis. Pharmacotherapy. (Systematic review of 13 large controlled trials of statins with at least 48 weeks of therapy in 43,390 patients; overall odds ratio for liver test abnormalities with statins versus placebo was 1.26; lovastatin 1.78; simvastatin 1.06; pravastatin 1.00, and fluvastatin, 3.54).
Charles EC, Olson KL, Sandhoff BG, McClure DL, Merenich JA. (2005). Evaluation of cases of severe statin-induced transaminitis within a large health maintenance organization. Am J Med. (Among 23,000 patients on statins in a health plan, 17 had ALT elevation >10 times ULN attributable to statin use; 10 on simvastatin, 5 lovastatin, and 2 atorvastatin; onset 2 days to 4 years after starting; 10 symptomatic; all resolved within 2-8 weeks, except one death; 3 of 7 recurred on rechallenge, 5 of 6 tolerated switching to another statin).
Tolman KG. (2002). The liver and lovastatin. Am J Cardiol. (In premarketing controlled trials of lovastatin, 21% of patients had ALT elevations, but only 1.9% had ALT >3 times ULN and rates were similar to comparator statins).
Parra JL, Reddy KR. (2003). Hepatotoxicity of hypolipidemic drugs. Clin Liver Dis. (Review and discussion of individual agents; lovastatin available since 1990 and linked to several case reports of hepatotoxicity).
Bays HE, Dujovne CA, McGovern ME, White TE, Kashyap ML, Hutcheson AG, Crouse JR, Advicor Versus Other Cholesterol-Modulating Agents Trial Evaluation. (2003). Comparison of once-daily, niacin extended-release/lovastatin with standard doses of atorvastatin and simvastatin(the Advicor Versus Other Cholesterol-Modulating Agents Trial Evaluation [ADVOCATE]). Am J Cardiol. (Controlled trial comparing lovastatin combined with niacin to atorvastatin or simvastatin alone in 315 patients for 16 weeks; no patient had confirmed ALT elevation >3 times ULN).
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al., Spanish Group for the Study of Drug-Induced Liver Disease. (2005). Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish registry over a 10-year period. Gastroenterology. (Analysis of 461 cases of drug induced liver disease 1984 to 2004 in Spanish Registry; 11 cases [2%] were attributed to “statins”, but no specific agent caused more than 4 cases).
Khorashadi S, Hasson NK, Cheung RC. (2006). Incidence of statin hepatotoxicity in patients with hepatitis C. Clin Gastroenterol Hepatol. (Electronic record review of rate of ALT elevations in patients with hepatitis C with or without statin therapy and controls on statin therapy found no differences between the three groups [20%, 24% and 17%]; severe abnormalities most frequent in patients with chronic hepatitis C not on statins [6.6% vs 1.2%]).
Silva MA, Swanson AC, Gandhi PJ, Tataronis GR. (2006). Statin-related adverse events: a meta-analysis. Clin Ther. (Metaanalysis of adverse event rates in 18 placebo controlled trials of six statins in 71,108 patients; ALT elevations >3 times ULN in 1.7% of statin vs 1.4% placebo recipients; event rates highest with atorvastatin, lowest with fluvastatin).
Law M, Rudnicka AR. (2006). Statin safety: a systematic review. Am J Cardiol. (Review of safety of statins; 38 cases of acute liver failure attributed to statins were submitted to MedWatch by end of 1999, which gives an estimated rate of 1 per million person years of use; rate of confirmed ALT elevations >3 times ULN is 0.1% with statins and 0.04% with placebo).
Dale KM, White CM, Henyan NN, Kluger J, Coleman CI. (2007). Impact of statin dosing intensity on transaminase and creatine kinase. Am J Med. (Metaanalysis of rates of ALT and CPK elevations in nine controlled studies comparing low vs high doses of statins; ALT elevations >3 times ULN occurred in 1.5% of high- and 0.4% of low-intensity statin groups, effect particularly seen with hydrophilic [pravastatin and atorvastatin] compared to lipophilic agents [simvastatin and lovastatin]).
Alsheikh-Ali AA, Karas RH. (2007). Safety of lovastatin/extended release niacin compared with lovastatin alone, atorvastatin alone, pravastatin alone, and simvastatin alone (from the United States Food and Drug Administration adverse event reporting system). Am J Cardiol. (Analysis of MedWatch reports of adverse events found no excess in liver related adverse event reports per million prescription due to lovastatin alone [2.3] vs niacin alone [2.5] vs the combination [3.2], but slightly higher rates with atorvastatin [4.5], simvastatin [5.7] and pravastatin [4.9], but data relied upon spontaneous reporting).
Bhardwah SS, Chalasani N. (2007). Lipid-lowering agents that cause drug-induced hepatotoxicity. Clin Liver Dis. (Review of hepatotoxicity of statins; reported rates of ALT or AST elevations >3 times ULN: atorvastatin 0.7%, fluvastatin 1.2%, lovastatin 0.6%, pravastatin 1.4%, rosuvastatin 0% and simvastatin 1.8%. Usually asymptomatic, individual case reports of autoimmune hepatitis).
Alsheikh-Ali AA, Maddukuri PV, Han H, Karas RH. (2007). Effect of the magnitude of lipid lowering on risk of elevated liver enzymes, rhabdomyolysis, and cancer: insights from large randomized statin trials. J Am Coll Cardiol. (Systematic review of relationship between LDL cholesterol lowering effects and adverse events in 23 statin treatment arms representing 309,506 person years of therapy; positive and graded relationship between statin dose [simvastatin, lovastatin and atorvastatin] and rates of ALT elevations, but no independent relationship to degree of LDL cholesterol decrease).
Stein CA, Goel S, Ghavamian R. (2007). Hepatitis and rhabdomyolysis in a patient with hormone refractory prostate cancer on ketoconazole and concurrent lovastatin therapy. Invest New Drugs. (84 year old man on long term lovastatin developed muscle weakness 4 weeks after starting ketoconazole [bilirubin and Alk P normal, ALT 829 U/L, CPK 47,250 U/L], suspected to be rhabdomyolysis caused by effects of ketoconazole on lovastatin pharmacokinetics, resolving in 3 weeks after stopping both).
Alsheikh-Ali A, Karas RH. (2007). Safety of lovastatin/extended release niacin compared with lovastatin alone, atorvastatin alone, pravastatin alone, and simvastatin alone. Am J Cardiol. (Review of MedWatch data base for serious adverse events: rates per million prescriptions were 11.2 for lovastatin/niacin ER; 11.6 niacin ER; 7.7 lovastatin; 19.6 atorvastatin; 22.6 simvastatin; 14.8 pravastatin. Hepatotoxicity [undefined] per million occurred in: 3.6 for lovastatin/ niacin ER; 2.4 niacin ER; 2.2 lovastatin; 4.2 atorvastatin; 5.9 simvastatin; 5.0 pravastatin).
Martin JE, Cavanaugh TM, Trumbull L, Bass M, Weber F, Aranda-Michel J, Hanaway M, et al. (2008). Incidence of adverse events with HMG-CoA reductase inhibitors in liver transplant patients. Clin Transplant. (Retrospective review of adverse events associated with statin and fibrate use in 69 patients with liver transplants; myalgias problematic in 5, myopathy in 1, but none had significant ALT elevations or hepatitis related to medication).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug-Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 3 cases were attributed to atorvastatin, 3 to simvastatin/ezetimibe, and one each to pravastatin, fluvastatin, and simvastatin [none attributed to lovastatin], but most cases were mild or not clearly attributable to the statin therapy).
Neuvonen PJ, Backman JT, Niemi M. (2008). Pharmacokinetic comparison of the potential over-the-counter statins simvastatin, lovastatin, fluvastatin and pravastatin. Clin Pharmacokinet. (Review of literature on pharmacokinetics of statins; simvastatin and lovastatin are metabolized extensively by the P450 system and levels are affected by inhibitors or inducers of CYP 3A4 [itraconazole, erythromycin, verapamil, diltiazem, cyclosporine], whereas fluvastatin and pravastatin are minimally, if at all, affected).
Avins AL, Manos MM, Ackerson L, Zhao W, Murphy R, Levin TR, Watson DJ, et al. (2008). Hepatic effects of lovastatin exposure in patients with liver disease: a retrospective cohort study. Drug Saf. (Analysis of electronic medical records on 93,106 patients, 14% of whom had received lovastatin; compared to controls, patients receiving lovastatin had lower rates of moderate ALT elevations and diagnosis of cirrhosis or liver failure compared to controls who did not receive lovastatin).
Roselle H, Ekatan A, Tzeng J, Sapienza M, Kocher J. (2008). Symptomatic hepatitis associated with the use of herbal red yeast rice. Ann Intern Med. (62 year old woman developed fever, nausea and fatigue 4 months after starting red yeast rice extract [ALT 211 U/L, bilirubin and Alk P not given], resolving within several months of stopping).
Grieco A, Miele L, Pompili M, Biolato M, Vecchio FM, Grattagliano I, Gasbarrini G. (2009). Acute hepatitis caused by a natural lipid-lowering product: when "alternative" medicine is no "alternative" at all. J Hepatol. (63 year old woman with ALT elevations after 6 months of lovastatin use, developed fatigue 6 months after starting a cholesterol lowering herbal preparation containing red yeast rice extract [bilirubin 1.9 mg/dL, ALT 1760 U/L, Alk P 722 U/L], resolving over the next 6 months, but with persistence of ALT elevations).
Russo MW, Scobey M, Bonkovsky HL. (2009). Drug-induced liver injury associated with statins. Semin Liver Dis. (Case reports linked to fluvastatin and atorvastatin and review of literature on statin related hepatotoxicity).
Becker DJ, Gordon RY, Halbert SC, French B, Morris PB, Rader DJ. (2009). Red yeast rice for dyslipidemia in statin-intolerant patients: a randomized trial. Ann Intern Med. (Controlled trial of red yeast rice extract vs placebo in 62 patients who had stopped statin therapy because of myalgias, found similar rates of myalgias [7% vs 3%] and no change in ALT or AST levels in both groups).
Halbert SC, French B, Gordon RY, Farrar JT, Schmitz K, Morris PB, Thompson PD, et al. (2010). Tolerability of red yeast rice (2,400 mg twice daily) versus pravastatin (20 mg twice daily) in patients with previous statin intolerance. Am J Cardiol. (43 patients with myalgias due to statin use were treated with pravastatin or red rice extract for 24 weeks; discontinuation due to myalgias occurred in 5% on red yeast rice extract and 9% on pravastatin, and mean ALT levels were similar between the 2 groups).
Gordon RY, Cooperman T, Obermeyer W, Becker DJ. (2010). Marked variability of monacolin levels in commercial red yeast rice products: buyer beware!. Arch Intern Med. (Among 12 red yeast rice extracts commercially available in the US, total monacolin concentrations varied from 0.3-11.1 mg/capsule, monacolin K by 0.1-10.1 mg/capsule, and citrinin [which is nephrotoxic] was present in 4).
Hippisley-Cox J, Coupland C. (2010). Unintended effects of statins in men and women in England and Wales: population based cohort study using the QResearch database. BMJ. (Among 225,922 new users of statins in a UK health care database, there was an increased risk of moderate or severe liver dysfunction [ALT >3 times ULN], usually within first 6 months and associated with higher doses of statins; relative risks were highest with fluvastatin [2.53 in women, 1.97 in men] and lowest with pravastatin [0.93 to 1.58]; there were too few persons treated with lovastatin for separate analysis).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury, of which 6 were attributed to statins: 2 atorvastatin, 2 simvastatin [one with ezetimibe] and 2 cerivastatin).
Björnsson E, Jacobsen EI, Kalaitzakis E. (2012). Hepatotoxicity associated with statins: reports of idiosyncratic liver injury post-marketing. J Hepatol. (Between 1988 and 2010, the Swedish registry received 217 adverse event reports possibly related to statins, 124 [57%] being liver related, 73 of which could be evaluated; 2 were fatal and one led to liver transplant; 3 had positive rechallenge; 43 [59%] were hepatocellular, 22 [30%] cholestatic and 8 [11%] mixed; 30 were due to atorvastatin, 28 simvastatin, 11 fluvastatin, 2 pravastatin, and 2 rosuvastatin, arising after 30-248 days; no mention of lovastatin).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 2 cases attributed to atorvastatin and 1 to simvastatin, but none to lovastatin).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to statins or lipid lowering agents).
Russo MW, Hoofnagle JH, Gu J, Fontana RJ, Barnhart H, Kleiner DE, Chalasani N, et al. (2014). Spectrum of statin hepatotoxicity: Experience of the drug-induced liver injury network. Hepatology. (Among 1,188 cases of drug induced liver disease collected in the US between 2004 to 2012, 22 [2%] were attributed to statins, including atorvastatin [8], simvastatin [5], rosuvastatin [4], fluvastatin [2], pravastatin [2] and lovastatin [1]; median age was 60 years and 68% were women; 9 cases were cholestatic and 12 hepatocellular [6 with autoimmune features]; the latency ranged widely, from 1 month to 10 years; only one case was fatal [a man with preexisting cirrhosis presenting with acute-on-chronic liver failure]).
Bays H, Cohen DE, Chalasani N, Harrison SA. (2014). An assessment by the Statin Liver Safety Task Force: 2014 update. J Clin Lipidol. (Review of the safety of statins including their use in patients with liver disease recommending that liver tests be obtained before therapy, but that routine monitoring is not necessary and that statins can be safety used in patients with nonalcoholic liver disease, and are probably safe in other forms of chronic liver disease and after liver transplantation).
Ooba N, Sato T, Wakana A, Orii T, Kitamura M, Kokan A, Kurata H, et al. (2014). A prospective stratified case-cohort study on statins and multiple adverse events in Japan. PLoS One. (Among 6877 patients started on statins between 2008 and 2010, 139 developed an increase in ALT or AST deemed likely due to the drug with no significant differences among those treated with pra-, ator-, flu-, pita- or rosu-vastatin).
Macedo AF, Taylor FC, Casas JP, Adler A, Prieto-Merino D, Ebrahim S. (2014). Unintended effects of statins from observational studies in the general population: systematic review and meta-analysis. BMC Med. (Systematic review of 90 studies of 48 different "unintended effects" of statins with evidence of an increased risk of myopathy [Odds Ratio: OR=2.6] and raised liver enzymes [OR=1.5]).
(2014). Drugs for lipids. Treat Guidel Med Lett. (Concise recommendations on management of hyperlipidemia mentions that 1-2% of patients on high doses of statins develop ALT elevations [above 3 times ULN], but that there is not always cross sensitivity to this side effect and that patients with mild-to-moderate ALT elevations can tolerate statins; no discussion of clinically apparent liver).
Perdices EV, Medina-Cáliz I, Hernando S, Ortega A, Martín-Ocaña F, Navarro JM, Peláez G, et al. (2014). Hepatotoxicity associated with statin use: analysis of the cases included in the Spanish Hepatotoxicity Registry. Rev Esp Enferm Dig. (Among 858 cases of drug induced liver injury enrolled in a Spanish Registry between 1994 and 2012, 47 [5.5%] were attributed to statins [16 atorvastatin, 13 simvastatin, 12 fluvastatin, 4 lovastatin and 2 pravastatin], usually with a hepatocellular pattern of injury, 8.5% with autoimmune features, chronic injury in 19%, and no liver related deaths).
Chen GL, Hsiao FY, Dong YH, Shen LJ, Wu FL. (2014). Statins and the risk of liver injury: a population-based case-control study. Pharmacoepidemiol Drug Saf. (Among 2165 Taiwanese patients hospitalized for liver injury between 2002 and 2009, use of statins was not more frequent than among 16,600 hospitalized controls, except for use of high doses of rosuvastatin [adjusted odds ratio of 2.29]).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 31 cases [3.4%] were attributed to statins, including 8 to atorvastatin, 8 simvastatin, 7 rosuvastatin, 4 pravastatin, 2 fluvastatin and 2 lovastatin).
Chang CH, Chang YC, Lee YC, Liu YC, Chuang LM, Lin JW. (2015). Severe hepatic injury associated with different statins in patients with chronic liver disease: a nationwide population-based cohort study. J Gastroenterol Hepatol. (Among 37,929 Taiwanese persons with chronic liver disease started on statin therapy for hyperlipidemia between 2005 and 2009, there were 912 incident cases of hospitalization for liver injury, rates being similar for the 6 different statins used [1.94-2.95 per 100,000 person-days], but higher in those on high doses of atorvastatin [40 or 80 mg daily]).
Kim HS, Lee SH, Kim H, Lee SH, Cho JH, Lee H, Yim HW, et al. (2016). Statin-related aminotransferase elevation according to baseline aminotransferases level in real practice in Korea. J Clin Pharm Ther. (Among 21,233 Korean patients starting statin therapy between 2009 and 2013, abnormal ALT or AST values above 3 times ULN were more frequent among those with mild baseline elevations).
Wang LY, Huang YS, Perng CL, Huang B, Lin HC. (2016). Statin-induced liver injury in an area endemic for hepatitis B virus infection: risk factors and outcome analysis. Br J Clin Pharmacol. (Analysis of the Taipei Veterans Hospital database from 2008 to 2012 identified 108 patients with statin-associated liver injury [including 28 rosu-, 20 flu-, 17 sim-, 11 pra-, 8 lo-, and 8 pita-vastatin] most of which 75 [69%] were mild and only one fatal [80 year old on rosuvastatin], and there were no differences in disease features or peak enzyme or bilirubin levels between HBsAg positive vs negative subjects [n=16 vs 92]).
Mazzanti G, Moro PA, Raschi E, Da Cas R, Menniti-Ippolito F. (2017). Adverse reactions to dietary supplements containing red yeast rice: assessment of cases from the Italian surveillance system. Br J Clin Pharmacol. (Among 1261 spontaneous adverse event reports made to an Italian surveillance system for natural health products between 2002 and 2015, 55 were for red yeast rice, including 10 for liver injury of which 6 were described as "hepatitis" and required hospitalization, ALT elevations 315 to 3566 U/L, bilirubin normal or minimally elevated, all resolving upon stopping supplements).
Björnsson ES. (2017). Hepatotoxicity of statins and other lipid-lowering agents. Liver Int. (Review of the hepatotoxicity of statins mentions that 12 cases of lovastatin induced liver injury have been published, but none were fatal or had a positive rechallenge).
Giugliano RP, Wiviott SD, Blazing MA, De Ferrari GM, Park JG, Murphy SA, White JA, et al. (2017). Long-term safety and efficacy of achieving very low levels of low-density lipoprotein cholesterol: a prespecified analysis of the IMPROVE-IT Trial. JAMA Cardiol. (Among 15,281 patients recovering from an acute cardiac syndrome treated with simvastatin [40 mg daily] with or without ezetimibe for up to 6 years, 6.4% achieved very low LDL-cholesterol levels [<30 mg/dL] and subsequently had low rates of cardiovascular events, but also no increase in rates of adverse events from statins such including ALT elevations above 3 times ULN [2.2% vs 1.8-2.1%]).
Liang X, He Q, Zhao Q. (2018). Effect of stains on LDL reduction and liver safety: a systematic review and meta-analysis. Biomed Res Int. (In a systematic review of 16 controlled trials of statins in 74,078 patients, rates of liver test abnormalities were higher with statin therapy [odds ratio, OR=1.18] but this was significant only for fluvastatin [OR=3.5] and with higher doses [40-80 mg daily] [OD=3.6] and was not significant for statins used at low or moderate doses).
Yebyo HG, Aschmann HE, Kaufmann M, Puhan MA. (2019). Comparative effectiveness and safety of statins as a class and of specific statins for primary prevention of cardiovascular disease: A systematic review, meta-analysis, and network meta-analysis of randomized trials with 94,283 participants. Am Heart J. (Metaanalyses of 40 trials of statins that enrolled 94,283 patients followed for a median of 1 year for efficacy and safety reported that statins as a class increased the risk of hepatic dysfunction by 6% with fluvastatin having the highest relative risk).
(2019). Lipid-lowering drugs. Med Lett Drugs Ther. (Concise review of the mechanism of action, relative efficacy, safety and costs of lipid lowering drugs including statins, ezetimibe, PCSK9 inhibitors, bile acid sequestrants, fibric acid derivatives niacin and fish oil, mentions that statin therapy is associated with ALT elevations above 3 times ULN in 1-3% of patients but “whether statins actually cause liver damage is unclear”).
Simon TG. (2020). When less is more: dosing simvastatin in decompensated cirrhosis. Lancet Gastroenterol Hepatol. (Editorial in response to Pose et al [2020] discusses the possible beneficial effects of statins in patients with cirrhosis and the issue of increased rate of muscle toxicity with 40 vs to 20 mg daily).
Hopewell JC, Offer A, Haynes R, Bowman L, Li J, Chen F, Bulbulia R, et al. (2020). Independent risk factors for simvastatin-related myopathy and relevance to different types of muscle symptom. Eur Heart J. (In a combined analysis of 3 large clinical trials in patients with cardiovascular disease treated with simvastatin for a mean of 3.4 years, 171 of 58,390 participants [0.1%] developed myopathy [muscle pain and CK levels above 10 times ULN], and risk was higher with higher doses, in Asian subjects, women, and persons with higher BMI and multiple comorbidities as well as with SLCO1B1 genotype).
Balasubramanian R, Maideen NMP. (2021). HMG-CoA reductase inhibitors (statins) and their drug interactions involving CYP enzymes, P-glycoprotein and OATP transporters-an overview. Curr Drug Metab. (Systematic review of literature on drug-drug interactions with statins and their clinical significance mentions that toxicity can be enhanced by inhibitors of CYP3A4 [atorva-, simva- and lova-statin] as well as by inhibitors of P glycoprotein and OATP1B1 [most statins including rosuvastatin] with specific recommendations for the most common inhibitors).
Sung S, Al-Karaghouli M, Kalainy S, Cabrera Garcia L, Abraldes JG. (2021). A systematic review on pharmacokinetics, cardiovascular outcomes and safety profiles of statins in cirrhosis. BMC Gastroenterol. (Systematic review of literature suggests that rosuvastatin and pitavastatin pharmacokinetics are unchanged in patients with Child’s Class A cirrhosis as opposed to atorvastatin and pravastatin, although unlike rosuvastatin, simvastatin, atorvastatin and pravastatin have been assessed in clinical trials in cirrhotic patients).
Lu B, Sun L, Seraydarian M, Hoffmann TJ, Medina MW, Risch N, Iribarren C, et al. (2021). Effect of SLCO1B1 T521C on statin-related myotoxicity with use of lovastatin and atorvastatin. Clin Pharmacol Ther. (Among 233 patients with statin associated myopathy and 2342 controls selected from an aging cohort with genetic testing, the allele frequency of c.521T>C in SLCO1B1 [rs4149056] was higher in those with myopathy, C allele frequency being 14-15% of controls compared to 17% of atorvastatin [p=0.4], 19% of lovastatin [p<0.001], and 25% of simvastatin [p<0.001] myopathy cases).
Cai T, Abel L, Langford O, Monaghan G, Aronson JK, Stevens RJ, Lay-Flurrie S, et al. (2021). Associations between statins and adverse events in primary prevention of cardiovascular disease: systematic review with pairwise, network, and dose-response meta-analyses. BMJ. (Systematic review of placebo controlled trials of statins for cardiovascular disease prevention identified 62 publications with 120,456 patients and found an increased risk of muscle symptoms, liver test abnormalities, renal insufficiency and eye conditions for all 7 statins, but not muscle disorders or diabetes; rosuvastatin having relatively high risk for muscle symptoms and renal abnormalities and also was also associated with eye conditions and diabetes, while atorvastatin and lovastatin had highest risk for liver abnormalities).
Karampoor S, Hesamizadeh K, Shams Z, Ghafari Novin A, Farahmand M, Zahednasab H, Mirzaei R, et al. The role of lovastatin in the attenuation of COVID-19. Int Immunopharmacol. 2021;101(Pt A):108192. (Among 284 patients with COVID-19 admitted to the intensive care unit, mortality rates were lower in those receiving 20 mg [n=99] or 40 mg [n=93] of lovastatin daily [0% and 2%] than in 92 controls [4%] while changes in serum aminotransferase levels were similar in all three groups).

## OTHER REFERENCE LINKS

1 Recent References on Lovastatin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=lovastatin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Lovastatin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=lovastatin)